# Avacopan

## OVERVIEW

### Introduction

Avacopan is an orally available, complement factor 5a receptor antagonist that is used to treat adults with severe antineutrophil cytoplasmic autoantibody-associated vasculitis. Avacopan is associated with an appreciable rate of serum aminotransferase elevations during therapy and has been linked to rare instances of clinically apparent liver injury with jaundice.

### Background

Avacopan (av” a koe’ pan) is an orally available, small molecule antagonist of the complement factor 5a receptor that is used to treat adults with severe vasculitis associated with antineutrophil cytoplasmic autoantibody (ANCA). The two major forms of ANCA-associated vasculitis are granulomatosis with polyangiitis (GPA; formerly known as Wegener’s granulomatosis) and microscopic polyangiitis (MPA). Both forms are considered autoimmune disorders and affect multiple organs, most commonly the kidneys and respiratory tract with damage to the small and medium sized arteries. ANCA-associated vasculitis is associated with activation of alternative complement pathways and activation of C5a on neutrophils, leading to inflammation and vascular cell injury. Inhibition of this complement pathway by avacopan has been shown to decrease both the frequency and the severity of the symptoms and signs of ANCA-associated vasculitis. Avacopan was approved for use in the United States in 2021, and current indications are for treatment of adults with severe ANCA-positive-associated vasculitis either in the form of granulomatosis with polyangiitis or microscopic polyangiitis. Avacopan is given in combination with standard therapies of these conditions including corticosteroids, cyclophosphamide, and rituximab. Avacopan is available in capsules of 10 mg under the brand name Tavneos. The recommended dose is 30 mg twice daily. Avacopan is a substrate of CYP 3A4 and is sensitive to its induction and inhibition. Contraindications to avacopan include cirrhosis and concurrent use of CYP 3A4 inhibitors (such as itraconazole, clarithromycin, and ritonavir). Side effects can include nausea, vomiting, diarrhea, abdominal pain, fatigue, headache, dizziness, paresthesia, and rash. Uncommon, but potentially severe, adverse events include hypersensitivity reactions (such as angioedema), liver injury, renal injury, reactivation of hepatitis B, and infections.

### Hepatotoxicity

In a preregistration randomized controlled trial, serum ALT or AST elevations occurred in 12% of patients taking avacopan vs 13% of placebo recipients. The elevations were largely asymptomatic and transient, resolving promptly after stopping therapy and sometimes despite drug continuation. Nevertheless, some elevations appeared to be related to therapy and arose most frequently during the first few months of treatment. Serious hepatic adverse events with aminotransferase elevations above 3 times the upper limit of normal occurred in 9 avacopan-treated (5.4%) vs 6 (3.6%) receiving a tapering regimen of corticosteroids without avacopan. Four of the 9 were considered probable or highly likely drug induced liver injury. Because patients with ANCA-associated vasculitis frequently receive multiple agents capable of causing liver injury (such as cyclophosphamide, rituximab, sulfamethoxazole), it is not always possible to incriminate avacopan definitively as the cause. The aminotransferase abnormalities resolved in all 9 patients once avacopan was discontinued. Bilirubin elevations were rare and there were no instances of clinically apparent liver injury with jaundice in preregistration clinical studies. Because of the aminotransferase elevations, a warning about drug induced liver injury was put in the product label, and monitoring liver tests before and monthly for 6 months after starting therapy was recommended. Since approval of avacopan and its more widescale use, several fairly severe cases of cholestatic hepatitis with jaundice have been reported, mostly from Japan. The latency to onset was typically 4 weeks and the enzyme pattern was cholestatic with or without accompanying immune allergic or autoimmune features.

Avacopan is an immunosuppressive agent and has the potential of causing reactivation of latent viral infections including hepatitis B. In pooled results from 239 patients in preregistration studies of avacopan, hepatitis B virus (HBV) reactivation occurred in two. However, both patients received other therapies capable of inducing HBV reactivation (cyclophosphamide, rituximab, corticosteroids), and minimal details of the 2 cases were provided. Nevertheless, patients with ANCA-associated vasculitis in whom therapy is planned should be screened for evidence of ongoing or previous HBV infection with tests for HBsAg and anti-HBc. Patients with HBsAg should receive prophylaxis using an oral antiviral agent with potent activity against HBV (tenofovir or entecavir) during therapy. Patients with anti-HBc without HBsAg might be monitored during therapy for evidence of viral reactivation and treated if HBV DNA or HBsAg become detected. Such patients might also benefit from HBV vaccination to boost anti-HBs titers before starting therapy.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which avacopan causes liver injury is unclear, but it is likely idiosyncratic and immune mediated. Avacopan is metabolized in the liver primarily by CYP 3A4 and inhibitors of this isoenzyme (such as itraconazole, cimetidine and ciprofloxacin) can result in higher drug levels and possibly increased rate of adverse events.

### Outcome and Management

The product label for avacopan has a warning about drug induced liver injury and recommends assessing symptoms and laboratory features of liver disease before starting therapy and monitoring routine liver tests monthly for the first 6 months of therapy and thereafter if signs of symptoms of liver injury arise. Avacopan should be discontinued if ALT or AST levels rise to above 5 times ULN or above 3 times ULN if symptoms or jaundice are present. Patients found to have serum aminotransferase elevations should be followed more carefully until they resolve. Avacopan is not recommended for persons with cirrhosis or active or uncontrolled liver disease and should be used with caution in those with liver test abnormalities at baseline.

Drug Class: Immunosuppressive Agents; Complement Inhibitors

Other Complement Inhibitors: Eculizumab, Ravulizumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Avacopan – Tavneos®

DRUG CLASS

Immunosuppressive Agents

COMPLETE LABELING (http://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Avacopan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Avacopan | 1346623-17-3 | C33-H35-F4-N3-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 October 2024

Abbreviations: ANCA, Antineutrophil cytoplasmic autoantibody; C5aR, complement factor 5a receptor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of complement receptor antagonists).
FDA. Multidiscipline Review. 2021.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214487Orig1s000MultidisciplineR.pdf (FDA website with product label and clinical review of data on avacopan provided by the sponsor in support of its approval as therapy of ANCA-associated vasculitis, mentions that in a pooled analysis of safety in 237 patients, hepatobiliary adverse events arose in 6% vs 1.8%, which were severe in 3.6% vs 0.6% and led to early discontinuation in 3% vs 0.6%. Of 9 hepatic severe adverse events analyzed in detail, 4 were considered drug induced liver injury, but none resulted in death or liver transplantation).
Jayne DRW, Bruchfeld AN, Harper L, Schaier M, Venning MC, Hamilton P, Burst V, Get al.; CLEAR Study Group. Randomized trial of C5a receptor inhibitor avacopan in ANCA-associated vasculitis. J Am Soc Nephrol. 2017;28:2756-2767. (Among 67 patients with newly diagnosed or relapsed ANCA-associated vasculitis treated with avacopan alone, avacopan with prednisone [20 mg], or placebo with prednisone [60 mg] daily for 12 weeks, clinical responses were higher with avacopan [81% and 86% vs 70%], while total adverse event rates were similar, and ALT elevations above 3 times ULN occurred in 5% of all three groups, one patient on avacopan alone developed marked liver and pancreatic enzyme elevations requiring discontinuation). 28400446
Merkel PA, Niles J, Jimenez R, Spiera RF, Rovin BH, Bomback A, Pagnoux C, et al.; CLASSIC Investigators. Adjunctive treatment with avacopan, an oral C5a receptor inhibitor, in patients with antineutrophil cytoplasmic antibody-associated vasculitis. ACR Open Rheumatol. 2020;2:662-671. (Among 42 patients with ANCA-associated vasculitis treated with standard of care [rituximab or cyclophosphamide] and avacopan [10 or 30 mg] or placebo twice daily for 12 weeks, response rates were high in all three groups [92% and 80% vs 85%], and adverse event rates were similar in the avacopan and placebo groups, including infections [24% vs 15%], severe adverse events [17% vs 15%], and discontinuations because of adverse events [14% vs 15%]; no mention of ALT elevations or hepatotoxicity). 33128347
Jayne DRW, Merkel PA, Schall TJ, Bekker P; ADVOCATE Study Group. Avacopan for the treatment of ANCA-associated vasculitis. N Engl J Med. 2021;384:599-609. (Among 331 adults with ANCA-associated vasculitis treated with avacopan [30 mg] twice daily vs a tapering dose regimen of prednisone [both groups also received rituximab or cyclophosphamide], the sustained remission rate at 52 weeks was 66% vs 55%, with serious adverse event rates of 37% vs 39%, including serious infections in 13% vs 15% [including a case of reactivation of hepatitis B], and serious liver related adverse events in 5.4% vs 3.7%, all of which resolved upon stopping). 33596356
Lee A. Avacopan: first approval. Drugs. 2022;82:79-85. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of avacopan shortly after its initial approval as therapy of ANCA-associated vasculitis mentions that serious cases of hepatotoxicity have been reported, although in preregistration clinical trials hepatic adverse events occurred in 13% on avacopan vs 12% on corticosteroids which were considered severe in 5.4% vs 3.7%; at least two cases of reactivation of hepatitis B has been reported in treated patients, although both had received other agents known to be associated with reactivation [cyclophosphamide and rituximab as well as corticosteroids]). 34826105
van Leeuwen JR, Popov T, Obergfell A, Rabelink TJ, Teng YKO. Preliminary assessment of safety and tolerability of avacopan during the early access program for ANCA-associated vasculitis. Biologics. 2023;17:11-14. (Among 30 patients with ANCA-associated vasculitis treated with avacopan [30 mg twice daily] in a European early access program for an average of 12 months, 24 adverse events were reported occurring in 8 patients including 15 serious adverse events in 5 patients, the events were largely renal dysfunction and infections, and none were hepatic). 36721867
Kojima K, Fukui S, Tanigawa M, Sumiyoshi R, Koga T, Shimakura A, Okano S, Kawakami A. Severe prolonged liver abnormality with jaundice during treatment for granulomatosis with polyangiitis with rituximab and avacopan. Rheumatology (Oxford). 2024;63:e101-e103. (76 year old Japanese woman with ANCA-associated granulomatosis with polyangiitis treated with rituximab and avacopan for 4 weeks developed jaundice [bilirubin 2.2 rising to 14 mg/dL, ALT to 395 U/L, Alk P to 686 U/L], with biopsy showing bland cholestasis with focal necrosis and with prolonged jaundice and persistent Alk P elevations). 37740250
Yamaguchi S, Yamazaki M, Kido T, Hounoki H, Muraishi N, Tajiri K, Tanaka S, et al. A case of vanishing bile duct syndrome during treatment of microscopic polyangiitis with avacopan. Rheumatology (Oxford). 2024;63:e120-e122. (75 year old Japanese woman with ANCA-associated microscopic polyangiitis developed jaundice 45 days after starting avacopan [bilirubin 7.7 rising to 26.0 mg/dL, ALT 565 U/L, GGT 654 U/L], improving gradually after stopping, liver biopsy showing bile duct paucity, remaining jaundiced with GGT elevations for more than 5 months). 37307092
Zonozi R, Aqeel F, Le D, Cortazar FB, Thaker J, Zabala Ramirez MJ, Sattui Cortes SE, et al. Real-world experience with avacopan in antineutrophil cytoplasmic autoantibody-associated vasculitis. Kidney Int Rep. 2024;9:1783-1791. (Among 92 patients with ANCA-associated vasculitis treated with avacopan for 52 weeks in 12 US medical centers, clinical responses were achieved in 84%, and 18 patients (20%) discontinued therapy early because of adverse events including 4 for elevations in serum aminotransferase levels which were above 3 times ULN in 2, all of which resolved after stopping). 38899183
Miao S, Suso P, Furst JA, Hudson MG, Trivedi A. Effect of mild or moderate hepatic impairment on the pharmacokinetics of avacopan, a small-molecule complement C5a receptor antagonist, for the treatment of antineutrophil cytoplasmic autoantibody-associated vasculitis. Clin Pharmacol Drug Dev. 2024;13:1000-1010. (Among 24 volunteers undergoing a single dose pharmacokinetic study of avacopan [30 mg], peak plasma levels and area under the curve of plasma levels were similar in 8 healthy controls, 8 persons with mild [Child-Pugh Class A] and 8 with moderate [Class B] hepatic dysfunction suggesting that dose adjustment is not necessary for mild-to-moderate hepatic dysfunction). 38993026
Uchida T, Fukui S, Iwamoto N, Umetsu A, Okamoto M, Fujikawa K, Mizokami A, et al. Absence of glucocorticoids concomitant with avacopan and subsequent liver injury in antineutrophil cytoplasmic antibody-associated vasculitis. 2024;51:1146-1148. (Among 36 Japanese adults with ANCA-associated polyangiitis treated with avacopan, 6 developed aminotransferase elevations [peak values 149 to 624 U/L], 2 with concurrent bilirubin elevations [peak levels 14.1 and 14.9 mg/dL] which resolved after stopping therapy; corticosteroid therapy was less frequent in those with liver injury [50% vs 90%] and none had received intravenous steroids [0% vs 43%], suggesting that concurrent corticosteroid therapy may ameliorate or prevent avacopan hepatic injury).
Nishino T, Tomori S, Haruyama M, Takahashi K, Mimaki M. A case of rapid avacopan-induced liver injury in pediatric granulomatosis with polyangiitis. Pediatr Nephrol. 2024;39:2919-2922. (A 10 year old Japanese boy with granulomatosis and polyangiitis developed liver test abnormalities 31 days after starting rituximab [375 mg/m^2^ every 7 days] and avacopan [30 mg twice daily] that followed methylprednisolone pulse therapy [bilirubin 0.6 mg/dL, ALT 1145 U/L, GGT 616 U/L, INR 0.9], which resolved after stopping therapy and with prednisone and ursodiol therapy). 38619581
Bomback AS, Herlitz LC, Kedia PP, Petersen J, Yue H, Lafayette RA. Safety and efficacy of avacopan in patients with C3 glomerulopathy: randomized, double-blind clinical trial. J Am Soc Nephrol. 2024 Oct 11. Epub ahead of print. (Among 57 patients with complement 3 [C3] glomerulopathy treated with avacopan [30 mg] or placebo twice daily for 52 weeks, there were no differences between the 2 groups in renal function or histologic outcomes, total adverse event rates [93% vs 86%], liver related events, and changes in chemistry laboratory values). 39392695

## OTHER REFERENCE LINKS

1. Recent References on Avacopan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Avacopan/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Avacopan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Avacopan)